# Axitinib

## OVERVIEW

### Introduction

Axitinib is an oral tyrosine kinase inhibitor selective for vascular endothelial growth factor (VEGF) receptors -1, -2 and -3 that is used in the therapy of advanced renal cell carcinoma. Axitinib therapy by itself is commonly associated with transient elevations in serum aminotransferase levels that are generally mild and asymptomatic and has been linked to rare instances of clinically apparent liver injury. When combined with an immune checkpoint inhibitor, as is now common, liver test abnormalities are considerably more frequent and more severe.

### Background

Axitinib (ax i’ ti nib) is an orally available tyrosine kinase inhibitor with activity against the receptors for vascular endothelial growth factor (VEGF). Engagement of these receptors by VEGF is associated with cell growth and angiogenesis, pathways that stimulate tumor growth. Axitinib also has activity against c-KIT (a tyrosine kinase receptor, mutations of which are found in gastrointestinal stromal tumors), and against the platelet derived growth factor (PDGF) receptor. Preclinical studies demonstrated that axitinib has activity against several solid tumors in animal models. Clinical trials of axitinib in malignant diseases in humans showed activity against renal cell carcinoma and lesser effects in breast and gastric cancer. Axitinib received approval for use in the United States in 2012 for therapy of refractory, advanced renal cell carcinoma. In 2019, the indications were expanded to therapy of advanced renal cell carcinoma in combination with either of two immune checkpoint inhibitors, avelumab or pembrolizumab. Axitinib is available in tablets of 1 and 5 mg under the brand name Inlyta. The typical dose is 5 mg twice daily, which can be increased to 7 or 10 mg twice daily if well tolerated, or reduced to 3 or 2 mg twice daily for side effects. Common side effects include fatigue, diarrhea, hypertension, anorexia, weight loss, nausea, hoarseness, hand-foot syndrome, constipation, arthralgias, abdominal discomfort, headache and rash. Uncommon but potentially severe side effects include arterial and venous thromboembolism, hemorrhage, cardiac failure, gastrointestinal perforation and fistula formation, thyroid dysfunction, liver injury, impaired wound healing, proteinuria, reversible posterior leukoencephalopathy syndrome, and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of axitinib, elevations in serum aminotransferase levels were common, occurring in up to 22% of patients. Values greater than 5 times the upper limit of normal (ULN), however, were uncommon, occurring in 1% to 2% of recipients. Furthermore, no instances of clinically apparent liver injury from axitinib were reported in prelicensure studies. Nevertheless, periodic monitoring of liver tests during axitinib therapy was recommended.

Rates of liver test abnormalities were higher when axitinib was combined with an immune check point inhibitor than when given alone. In randomized trials in support of combination therapy of axitinib with avelumab or pembrolizumab, ALT elevations arose in 50% to 60% of patients and were above 5 times ULN in 9% to 20%. Furthermore, liver injury led to permanent discontinuation of one or both agents in 6% to 7%. Importantly, when the two drugs were restarted separately after the enzyme elevations resolved, recurrence was more common with axitinib alone [24% to 37%] than with the check point inhibitor [16%]. Among 92 patients rechallenged after the axitinib-avelumab vs axitinib-pembrolizumab combination, ALT elevations recurred in 33% vs 44% given both, 24% and 47% given axitinib alone, but in only 16% (1 of 6) given the check point inhibitor alone. These findings suggest that the check point inhibitor may increase the risk of axitinib hepatotoxicity and that therapy with the monoclonal antibody alone might be continued.

Since approval of the combination of axitinib with pembrolizumab or avelumab, several case reports of liver injury attributed to axitinib have been published. Injury generally arose after 2 to 6 months of treatment and both hepatocellular and cholestatic patterns of injury occurred. Most cases resolved once the two agents were withdrawn and rechallenge with one or the other individually may demonstrate which is the major culprit.

Likelihood score: C (probable uncommon cause of clinically apparent liver injury, most often when combined with an immune checkpoint inhibitor).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during axitinib therapy is not known. Axitinib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Axitinib is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity, and dose reduction is recommended when a strong CYP 3A4 inhibitor cannot be avoided.

### Outcome and Management

Clinically apparent liver injury due to axitinib is uncommon but convincing cases have been published particularly when it is combined with immune check point inhibitors. The product label for axitinib recommends monitoring routine liver tests before starting and periodically afterwards, especially when combined with avelumab or pembrolizumab. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Corticosteroids are often given when liver injury arises during combination therapy as is typically done for immune check point inhibitor induced hepatitis, which is thought to be immune mediated. Liver tests typically improve promptly on stopping axitinib and chronic hepatitis and vanishing bile duct syndrome have not been reported. There does not appear to be cross reactivity in risk for hepatic injury between axitinib and other tyrosine kinase inhibitors and, in some situations, switching to another tyrosine kinase receptor inhibitor may be appropriate. When liver injury arises during combination therapy, sequential rechallenge with each agent separately with careful monitoring of liver test results can help identify which one is responsible.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Axitinib – Inlyta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Axitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Axitinib | 319460-85-0 | C22-H18-N4-O-S | SID: 135236613

## ANNOTATED BIBLIOGRAPHY

References updated: 05 August 2026

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors such as axitinib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; imatinib, gefitinib, erlotinib and crizotinib are discussed, but not axitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA@Drugs: 2012 https://www.accessdata.fda.gov/drugsatfda_docs/nda/2012/202324Orig1s000MedR.pdf (FDA Drug Approvals website with product labels and the full FDA clinical review of data submitted on the safety and efficacy of axitinib in support of its approval mentions that, in a controlled trial, ALT elevations arose in 22% of patients receiving axitinib but also in 22% of those on sorafenib [the comparator arm], and few of the elevations were above 5 times ULN, and none were accompanied by jaundice or led to drug discontinuation).
FDA@Drugs: 2024 https://www.accessdata.fda.gov/drugsatfda_docs/label/2024/202324s016lbl.pdf (Current product label for axitinib carries a warning for hepatotoxicity, noting that liver enzyme elevations occurred with axitinib alone and that higher frequencies of ALT elevations above 5 times ULN occurred when it was combined with avelumab [9%] or pembrolizumab [20%]; the label describes recurrence of ALT elevations on rechallenge with axitinib in 6 of 25 [24%] who received avelumab and 16 of 34 [47%] who received pembrolizumab, and of those who relapsed on rechallenge, 95% resolved completely during short term follow up once therapy was stopped).
Rixe O, Bukowski RM, Michaelson MD, Wilding G, Hudes GR, Bolte O, Motzer RJ, et al. Axitinib treatment in patients with cytokine-refractory metastatic renal-cell cancer: a phase II study. Lancet Oncol 2007; 8: 975-84. PMID: (Among 52 patients with metastatic renal cell cancer treated with axitinib, objective responses occurred in 44%; common side effects included fatigue, hypertension and diarrhea; no mention of ALT elevations or hepatotoxicity). 17959415
Fruehauf J, Lutzky J, McDermott D, Brown CK, Meric JB, Rosbrook B, Shalinsky DR, et al. Multicenter, phase II study of axitinib, a selective second-generation inhibitor of vascular endothelial growth factor receptors 1, 2, and 3, in patients with metastatic melanoma. Clin Cancer Res 2011; 17: 7462-9. PMID: (Among 32 patients with refractory melanoma, 37% showed some evidence of beneficial response to axitinib; rates of ALT elevations and hepatotoxicity were not mentioned). 21976544
Rugo HS, Stopeck AT, Joy AA, Chan S, Verma S, Lluch A, Liau KF, et al. Randomized, placebo-controlled, double-blind, phase II study of axitinib plus docetaxel versus docetaxel plus placebo in patients with metastatic breast cancer. J Clin Oncol 2011; 29: 2459-65. PMID: (Among 168 patients with refractory metastatic breast cancer, objective responses occurred in 24% on docetaxel alone vs 44% on docetaxel and axitinib; side effects were greater with combination therapy, but ALT elevations and hepatotoxicity were not mentioned). 21555686
Rini BI, Escudier B, Tomczak P, Kaprin A, Szczylik C, Hutson TE, Michaelson MD, et al. Comparative effectiveness of axitinib versus sorafenib in advanced renal cell carcinoma (AXIS): a randomised phase 3 trial. Lancet 2011; 378 (9807): 1931-9. PMID: (Among 723 patients with advanced renal cell carcinoma, progression free survival was longer with axitinib [6.7 months] than sorafenib [4.7 months], but side effects were common, although rates of hepatotoxicity or ALT elevations were not provided). 22056247
Axitinib (Inlyta) for advanced renal cell carcinoma. Med Lett Drugs Ther 2012; 54 (1392): 47-8. PMID: (Concise review of the pharmacology, efficacy and safety of axitinib for renal cell carcinoma shortly after its approval in the United States mentions that side effects can include elevations in serum aminotransferase levels). 22683928
Motzer RJ, Escudier B, Tomczak P, Hutson TE, Michaelson MD, Negrier S, Oudard S, et al. Axitinib versus sorafenib as second-line treatment for advanced renal cell carcinoma: overall survival analysis and updated results from a randomised phase 3 trial. Lancet Oncol 2013; 14: 552-62. PMID: (Among 723 patients with metastatic renal cell cancer treated with either axitinib or sorafenib, median overall survivals were similar with both agents [20.1 vs 19.2 months] and side effects were common; no mention of ALT elevations or hepatotoxicity). 23598172
Hutson TE, Lesovoy V, Al-Shukri S, Stus VP, Lipatov ON, Bair AH, Rosbrook B, et al. Axitinib versus sorafenib as first-line therapy in patients with metastatic renal-cell carcinoma: a randomised open-label phase 3 trial. Lancet Oncol 2013; 14: 1287-94. PMID: (Among 288 patients with metastatic renal cell carcinoma treated with either axitinib or sorafenib, progression free survival was similar in the two groups; side effects of diarrhea, hypertension, anorexia, weight loss and hoarseness were more common with axitinib; rates of ALT elevations and hepatotoxicity were not reported). 24206640
Rini BI, Melichar B, Ueda T, Grünwald V, Fishman MN, Arranz JA, Bair AH, et al. Axitinib with or without dose titration for first-line metastatic renal-cell carcinoma: a randomized double-blind phase 2 trial. Lancet Oncol 2013; 14: 1233-42. PMID: (Among 213 patients with metastatic renal cell carcinoma treated with standard or titrated doses of axitinib, side effects were more common with high doses, particularly hypertension, hand-foot syndrome, and vomiting; ALT elevations occurred in 9% of patients but were above 5 times ULN in only 2%). 24140184
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. PMID: (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the United States as of 2013; axitinib has been reported to cause ALT elevations in up to 22% of patients [5 times ULN in < 1%], but has not been reported to cause hepatitis or hepatic failure). 23620168
Bracarda S, Castellano D, Procopio G, Sepúlveda JM, Sisani M, Verzoni E, Schmidinger M. Axitinib safety in metastatic renal cell carcinoma: suggestions for daily clinical practice based on case studies. Expert Opin Drug Saf 2014; 13: 497-510. PMID: (Review of published literature on side effects of axitinib and their management; no discussion of hepatotoxicity or ALT elevations). 24641566
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PMID: (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were due to antineoplastic agents, including 9 [1%] to protein kinase inhibitors, but none were attributed specifically to axitinib). 25754159
Miyake H, Harada KI, Ozono S, Fujisawa M. Assessment of efficacy, safety, and quality of life of 124 patients treated with axitinib as second-line therapy for metastatic renal-cell carcinoma: experience in real-world clinical practice in Japan. Clin Genitourin Cancer 2017; 15: 122-8. PMID: (Among 124 Japanese patients with renal cell carcinoma treated with axitinib, none had a complete response but 17% had a partial response, and side effects included hypertension [59%], dysphonia [55%], diarrhea [52%], hand-foot syndrome [50%], fatigue [43%] and hypothyroidism [43%]; no mention of ALT elevations or hepatotoxicity). 27473522
MacLean E, Cisar L, Mehle K, Eremina D, Quigley JM. Real-world axitinib use in the United States: a retrospective study using linked datasets. J Manag Care Spec Pharm 2016; 22: 723-32. PMID: (A "real-world" assessment of use of axitinib in the US made no mention of side effects or toxicity). 27231799
Kang YK, Yau T, Park JW, Lim HY, Lee TY, Obi S, Chan SL, et al. Randomized phase II study of axitinib versus placebo plus best supportive care in second-line treatment of advanced hepatocellular carcinoma. Ann Oncol 2015; 26: 2457-63. PMID: (Among 202 patients with advanced liver cancer treated with axitinib or placebo, overall survival was the same in the two groups, while side effects were more common with axitinib including ALT elevations [74% vs 51%] with values above 5 times ULN in 10% vs 4%, and one axitinib treated patient died of acute liver failure, although the patients in this trial had underlying chronic liver disease and advanced liver cancer). 26386123
Motzer RJ, Penkov K, Haanen J, Rini B, Albiges L, Campbell MT, Venugopal B, et al. Avelumab plus axitinib versus sunitinib for advanced renal-cell carcinoma. N Engl J Med 2019; 380: 1103-15. PMID: (Among 886 patients with untreated advanced renal cell carcinoma treated with avelumab [every 2 weeks] and axitinib [5 mg twice daily] or with sunitinib [50 mg daily for 4 weeks in 6- week cycles], progression free survival was longer with the combination [14 vs 8 months], and while overall adverse event rates were similar, ALT elevations arose in 17% vs 11% and were above 5 times ULN in 6% vs 2.5%). 30779531
Rini BI, Plimack ER, Stus V, Gafanov R, Hawkins R, Nosov D, Pouliot F, et al.; KEYNOTE-426 Investigators. Pembrolizumab plus axitinib versus sunitinib for advanced renal-cell carcinoma. N Engl J Med 2019; 380: 1116-27. PMID: (Among 861 patients with untreated advanced renal cell carcinoma treated with either pembrolizumab (200 mg iv every 3 weeks) and axitinib [5 mg twice daily] or with sunitinib [30 mg daily for 4 weeks of 6-week cycles], overall survival after 12.8 months of follow up was greater with the combination [90% vs 78%]; and while overall adverse event rates were similar, ALT elevations arose in 27% vs 15% and were above 5 times ULN in 13% vs 3%, although the only death from liver disease occurred in the sunitinib arm). 30779529
Lin ZZ, Chen BB, Hung YP, Huang PH, Shen YC, Shao YY, Hsu CH, et al. A multicenter phase II study of second-line axitinib for patients with advanced hepatocellular carcinoma failing first-line sorafenib monotherapy. Oncologist 2020; 25: e1280-e1285. PMID: (Among 45 Taiwanese patients with advanced liver cancer and compensated cirrhosis [82% due to hepatitis B] treated with axitinib [5 mg daily] after failure of sorafenib, the disease control rate was 62% and ALT elevations occurred in 49% which were above 5 times ULN in 18%). 32271494
Björnsson HK, Sverrisdottir A, Björnsson ES. DILI is rare amongst patients without liver metastases receiving cancer treatment in Iceland: a population-based cohort study. Scand J Gastroenterol 2022; 57: 856-61. PMID: (Among 11 patients with renal cell cancer treated with axitinib between 2007 and 2018 at a single referral hospital in Iceland, one [a 63 year old woman] developed evidence of liver injury [peak bilirubin 1.3 mg/dL, ALT 458 U/L, Alk P 209 U/L] but was asymptomatic and recovered without specific therapy. 35138984
Yeo YH, Ayoub W, Yang JD, Kuo A, Trivedi HD. Beyond the checkpoint: severe axitinib-induced liver injury. ACG Case Rep J 2023; 10: e01177. PMID: (61 year old man with metastatic renal cell carcinoma developed abnormal liver tests without symptoms 2 months after starting axitinib and pembrolizumab [bilirubin 0.5 mg/dL, ALT 702 U/L, Alk P 308 U/L], and values worsened despite stopping pembrolizumab [bilirubin 1.5 mg/dL, ALT 1233 U/L, Alk P 598 U/L], but improved when axitinib was stopped then rose again when axitinib alone was restarted [bilirubin 2.7 mg/dL, ALT 2003 U/L, Alk P 270 U/L] ultimately resolving when it was stopped again; while the injury appeared to be due to axitinib, the pembrolizumab by blocking tolerance may have acted synergistically]. 37937065
Di Marco A, Artioli G, Favaretto A, Cavasin N, Basso U. Multiorgan failure caused by pembrolizumab and axitinib in a woman affected by metastatic clear cell renal cell carcinoma: a case report and literature review. Medicine (Baltimore) 2024; 103: e37606. PMID: (Woman with metastatic renal cell carcinoma developed heart failure, oliguria and acute ischemic hepatitis after only 2 doses of pembrolizumab with axitinib, requiring intensive care and high dose corticosteroids, with full recovery). 38552059
Mobaraki S, Nissen PH, Donskov F, Wozniak A, Van Herck Y, Coosemans L, van Nieuwenhuyse T, et al. Cabozantinib induces isolated hyperbilirubinemia in renal cell carcinoma patients carrying the UGT1A1*28 polymorphism. Clin Genitourin Cancer 2024; 22: 102180. PMID: (Among 66 patients with renal cell carcinoma treated sequentially with pazopanib, cabozantinib or axitinib, bilirubin levels rose in carriers of the UGT1A1*28 variant during pazopanib and cabozantinib therapy but not during axitinib therapy, indicating that axitinib does not interfere with bilirubin conjugation). 39155162
Nonomura N, Ito T, Sato M, Morita M, Ogi M, Kajita M, Oya M. Final analysis of post-marketing surveillance for avelumab + axitinib in patients with renal cell carcinoma in Japan. Cancer Med 2025; 14: e70275. PMID: (Prospective postmarketing surveillance of 328 Japanese patients with renal cell carcinoma treated with avelumab and axitinib in routine practice; adverse drug reactions of interest arose in 53%, the third most common being hepatic disorders in 14%, and the safety profile matched that seen in the registration trial). 39838507
Rini BI, Plimack ER, Stus V, Gafanov R, Waddell T, Nosov D, Pouliot F, et al. Pembrolizumab plus axitinib versus sunitinib for advanced clear cell renal cell carcinoma: 5-year survival and biomarker analyses of the phase 3 KEYNOTE-426 trial. Nat Med 2025; 31: 3475-84. PMID: (Final follow up of the registration trial of axitinib and pembrolizumab vs sunitinib for advanced renal cell carcinoma [Rini 2019] showed overall 5-year survival of 42% vs 37% and progression free survival of 18% vs 7%, with no discussion of adverse events or changes in ALT). 40750932
Wang X, Chen R, Liu J, Wang E, Luo H. Liver injury related to vascular endothelial growth factor tyrosine kinase inhibitors: a pharmacovigilance analysis of the USA FDA adverse event reporting system (FAERS) database. Expert Opin Drug Saf 2026; 25: 1351-9. PMID: (Analysis of 8619 reports of liver injury attributed to 9 tyrosine kinase inhibitors of vascular endothelial growth factor receptors submitted to the FDAs Adverse Event Reporting System (FAERS) between 2006 and 2024; axitinib was among the implicated agents, but the strongest association was with pazopanib and the highest mortality with sorafenib; the median time to onset was 21 days). 39881499
Pichel RC, Miranda HM, Sá DC, Coelho JQ, Lopes PL, Ramos MJ, Viscaíno JR, Araújo A. Histologic findings of liver injury during pembrolizumab-axitinib treatment. Rev Esp Enferm Dig 2026; 118: 307-8. PMID: (69 year old man with advanced renal cell cancer developed jaundice and confusion 6 months after starting pembrolizumab and axitinib with markedly elevated aminotransferase levels and bilirubin [values not provided], liver biopsy showing changes of ischemic as well as inflammatory liver injury). 39930863

## OTHER REFERENCE LINKS

1. Recent References on Axitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Axitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Axitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Axitinib)